# Carmustine

## OVERVIEW

### Introduction

Carmustine (BCNU) is a parenterally administered alkylating agent used alone and in combination with other antineoplastic agents in the treatment of several forms of cancer including leukemias, lymphomas, and breast, testicular, ovarian, gastric and pancreatic cancer. Carmustine therapy is associated with minor transient serum enzyme elevations and has been linked to cases of acute liver injury including cholestatic hepatitis and acute veno-occlusive disease.

### Background

Carmustine (kar mus' teen), which is also known as BCNU, is a nitrosourea that acts as an alkylating agent and is used in the therapy of several forms of leukemia, lymphoma and solid organ cancer. Like cyclophosphamide, carmustine requires activation in the liver to form its active intermediates which act by modifying and cross linking purine bases in DNA, thus inhibiting DNA, RNA and protein synthesis and leading to cell death in rapidly dividing cells. Carmustine also forms adducts with intracellular proteins. Carmustine was approved for use in the United States in 1977, and its current uses include treatment of breast, gastric, liver, pancreatic, lung, brain, ovarian and testicular cancer, malignant melanoma, Hodgkin and non-Hodgkin lymphoma and multiple myeloma. Carmustine is given intravenously and is available in liquid formulations (100 mg vials) in generic forms and under the trade names Gliadel or BiCNU. Recommended doses vary by age, body weight and malignant condition. Carmustine is often given in combination with other antineoplastic agents or alone in cycles every 6 to 8 weeks. It is also available formulated in a wafer containing 7.7 mg of carmustine (Gliadel), which can be inserted in a surgical space such as the brain after resection of a high grade malignant glioma. The toxicity of carmustine is similar to other alkylating agents. Common side effects include alopecia, nausea, vomiting, diarrhea, gastrointestinal upset, nephrotoxicity, oral ulcers and bone marrow suppression.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels are found in up to 25% of patients treated with carmustine. Because carmustine is typically given in combination with other agents, its role in causing these serum enzyme elevations is not always clear. The abnormalities are generally transient, do not cause symptoms and do not require dose modification. Clinically apparent liver injury from carmustine has been limited to a small number of cases of cholestatic hepatitis and more frequent instances of sinusoidal obstruction syndrome, reported mostly with its use in high doses or as a conditioning agent in preparation for hematopoietic cell transplantation. The onset of sinusoidal obstruction syndrome is usually within two to three weeks of the myeloablation and is characterized by a sudden onset of abdominal pain, weight gain, ascites, marked increase in serum aminotransferase levels (and LDH), and subsequent jaundice and hepatic dysfunction. The severity of sinusoidal obstruction syndrome varies from a transient, self-limited injury to acute liver failure. The diagnosis of sinusoidal obstruction syndrome is usually based on clinical features of tenderness and enlargement of the liver, weight gain, ascites and jaundice occurring within 3 weeks of chemotherapy. Liver biopsy is diagnostic but often contraindicated, because of severe thrombocytopenia after hematopoietic cell transplantation.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury, particularly when used for myeloablation).

### Mechanism of Injury

Most instances of hepatotoxicity from carmustine appear dose related and probably due to direct cytotoxicity. The sinusoidal obstruction syndrome induced by alkylating agents is probably related to their toxic effect on sinusoidal cells in the liver, causing their necrosis and release into the sinusoids, with subsequent obstruction and obliteration of hepatic veins. Carmustine is extensively metabolized by the hepatic cytochrome P450 system.

### Outcome and Management

The severity of liver injury from carmustine ranges from mild elevations in liver enzymes, to a self limited cholestatic hepatitis to massive, fatal hepatic necrosis due to sinusoidal obstruction syndrome. There is currently no specific therapy for veno-occlusive disease other than supportive management and avoidance of further damage. Rechallenge should be avoided.

Drug Class: Antineoplastic Agents, Alkylating Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Carmustine – BiCNU, Gliadel®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Carmustine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Carmustine | 154-93-8 | C5-H9-Cl2-N3-O2 | Carmustine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 January 2017

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that carmustine has been linked to cases of hepatocellular injury with jaundice).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents lists carmustine as having liver test elevations in up to 25% of patients and being linked to occasional case report of injury and even fatalities).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics).
De Vita VT, Carbone PP, Owens AH Jr, Gold GL, Krant MJ, Edmonson J. Clinical trials with 1,3-bis(2-chloroethyl)-1-nitrosourea, NSC-409962. Cancer Res 1965; 25: 1876-81. (Preliminary studies of BCNU in 144 patients with malignancies using different dose schedules; AST elevations occurred in 15% after 13-63 days and were self-limited in all; liver toxicity may have contributed to the death of one patient). 5858571
Hansen HH, Selawry OS, Muggia FM, Walker MD. Clinical studies with 1-(2-chloroethyl)-3-cyclohexyl-1-nitrosourea (NSC 79037). Cancer Res 1971; 31: 223-7. (Preliminary studies of CCNU in 40 patients with malignancies; there was no consistent hepatic dysfunction; AST elevations occurred in one patient). 4926242
Young RC, De Vita VT, Serpick AA, Cancellos GP. Treatment of advanced Hodgkin's disease with [1,3-bis(2-chloroethyl)-1-nitrosourea] BCNU. N Engl J Med 1967; 285: 475-9. (Among 45 patients with refractory Hodgkin disease treated with carmustine, 21 [47%] achieved a remission; mentions that one patient who died had liver toxicity). 5558887
Walker MD, Hurwitz BS. BCNU(1,2-bis(2-chloroethyl)-1-nitrosourea; NSC-409962) in the treatment of malignant brain tumor- a preliminary report. Cancer Chemother Rep 1970; 54: 263-71. (Pilot study of carmustine in 27 patients with brain tumors mentions that there were mild elevations in AST and Alk P in a few patients, but that these rapidly returned to normal). 4946011
Lokich JJ, Drum DE, Kaplan W. Hepatic toxicity of nitrosourea analogues. Clin Pharmacol Ther 1974; 16: 363-7. (2 cases: 70 year old man with metastatic colon cancer and cirrhosis developed jaundice 6 weeks after a 5 day course of carmustine and streptozotocin [bilirubin 6.2 mg/dL], but no other information given; 66 year old man with pancreatic cancer developed jaundice 2 weeks after carmustine and streptozotocin [bilirubin 3.5 mg/dL, AST 30 U/L, Alk P 135 U/L], with recovery after stopping therapy). 4852251
Lessner HE, Vogler WR. Toxicity study of BCNU (NSC-409965) given orally. Cancer Chemother Rep 1974; 58: 407-11. (Pilot study of carmustine alone in various oral doses in 104 patients with cancer; two patients developed liver toxicity, one with jaundice and elevated Alk P, but relationship to drug was considered uncertain). 4601671
McIntyre RE, Magidson JG, Austin GE, Gale RP. Fatal veno-occlusive disease of the liver following high dose 1,3-bis(2-chloroethyl)-1-nitrosurea (BCNU) and autologus bone marrow transplantation. Am J Clin Pathol 1981; 75: 614-6. (22 year old woman with lymphoma developed fatal sinusoidal obstruction syndrome arising 18 days after bone marrow transplantation, preceded by myeloablation using high dose carmustine alone). 7013473
Brandes AA, Tosoni A, Amistà P, Nicolardi L, Grosso D, Berti F, Ermani M. How effective is BCNU in recurrent glioblastoma in the modern era? A phase II trial. Neurology 2004: 63: 1281-4. (Among 40 patients with recurrent glioblastoma treated with 100 cycles of carmustine, hepatotoxicity [grade 2 or 3] occurred in 4 patients [10%], abnormalities resolving on average within 2 months of stopping). 15477552
Wolff SN. High-dose carmustine and high-dose etoposide: a treatment regimen resulting in enhanced hepatic toxicity. Cancer Treat Rep 1986; 70: 1464-5. (Pilot study of high dose carmustine and etoposide in 4 patients with astrocytoma; 3 developed hepatotoxicity with ascites arising 1-2 months after starting therapy which was fatal in 2). 3791261
Phillips GL, Fay JW, Herzig GP, Herzig RH, Weiner RS, Wolff SN, Lazarus HM, et al. Intensive 1,3-bis(2-chloroethyl)-1-nitrosourea(BCNU), NSC #4366650 and cryopreserved autologous marrow transplantation for refractory cancer. A phase I-II study. Cancer 1983; 52: 1792-802. (Among 93 patients with refractory cancer treated with escalating doses of carmustine and hematopoietic cell transplantation, hepatotoxicity occurred in 29 [31%], which was severe in 10 and fatal in 8 [9%], marked by cholestasis and hepatic failure with centrolobular hepatic necrosis and sinusoidal obstruction syndrome (SOS) in some cases, mostly with higher doses). 6354414
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation 1987; 4: 778-83. (Among 235 patients undergoing hematopoietic cell transplantation between 1982 and 1985, sinusoidal obstruction syndrome [SOS] developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population). 3321587
Ahmed T, Ciavarella D, Feldman E, Ascensao J, Hussain F, Engelking C, Gingrich S, et al. High-dose, potentially myeloablative chemotherapy and autologous bone marrow transplantation for patients with advanced Hodgkin's disease. Leukemia 1989; 3: 19-22. (Among 23 patients with refractory Hodgkin disease treated with high doses of carmustine, etoposide and cyclophosphamide and autologous hematopoietic cell transplantation, 39% had liver test abnormalities and one died of hepatotoxicity; no details given). 2642573
Jones RB, Shpall EJ, Ross M, Coniglio D, Affronti ML, Peters WP. High-dose carboplatin, cyclophosphamide, and BCNU with autologous bone marrow support: excessive hepatic toxicity. Cancer Chemother Pharmacol 1990; 26: 155-6. (Among 4 patients given high dose carboplatin, cyclophosphamide and carmustine followed by hematopoietic cell transplantation for malignant melanoma, 3 developed severe SOS and two died and the fourth became jaundiced). 2189592
Bearman SI. The syndrome of hepatic veno-occlusive disease after marrow transplantation. Blood 1995; 85: 3005-20. (Review of sinusoidal obstruction syndrome after hematopoietic cell transplantation; usually presents with painful hepatomegaly, weight gain [fluid and ascites] and jaundice within 3 weeks of myeloablation, with occlusion of central veins and sinusoids and extensive zone 3 [centrolobular] injury). 7756636
Papadakis V, Dunkel IJ, Cramer LD, Kramer E, Papadopoulos E, Goldman S, Packer RJ, et al. High-dose carmustine, thiotepa and etoposide followed by autologous bone marrow rescue for the treatment of high risk central nervous system tumors. Bone Marrow Transplant 2000; 26: 153-60. (Among 42 patients with brain tumors who were treated with high dose carmustine, thiotepa and etoposide and autologous hematopoietic cell transplantation, 2 developed sinusoidal obstruction syndrome and 5 had transient elevations in ALT levels). 10918425
DeLeve LD, Shulman HM, McDonald GB. Toxic injury to hepatic sinusoids: sinusoidal obstruction syndrome. Semin Liver Dis 2002; 22: 27-41. (Review of clinical features, pathology, etiology, prevention and treatment of sinusoidal obstruction syndrome [SOS], a better term for this condition than veno-occlusive disease; first described in association with exposure to phytotoxins [pyrrolizidine alkaloids], the most common cause now is cancer chemotherapy and particularly myeloablative conditioning regimens in preparation for hematopoietic cell transplantation). 11928077
McDonald GB. Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology 2010; 51: 1450-60. (Review of liver complications of bone marrow [hematopoietic cell] transplantation, which have become less frequent with better understanding of their causes and means of prevention; the rate of SOS has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high doses of cyclophosphamide] and better understanding of pharmacokinetics of the alkylating agents). 20373370

## OTHER REFERENCE LINKS

1. Recent References on Carmustine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Carmustine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Carmustine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Carmustine)